# Dofetilide

## OVERVIEW

### Introduction

Dofetilide is an oral class III antiarrhythmic agent used for treatment and prevention of atrial fibrillation and flutter. Dofetilide has had limited clinical use, but has not been linked to an increased rate of serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Dofetilide (doe fet' i lide) is a methanesulfonamide antiarrhythmic agent that is used to treat and prevent recurrence of atrial fibrillation and flutter. Dofetilide is considered a class III antiarrhythmic as it appears to act on a delayed rectifier of a specific potassium channel which results in prolongation of the recovery phase and delay in spread of the action potential. Dofetilide has been shown to lead to spontaneous conversion to normal sinus rhythm in up to 30% of patients with atrial fibrillation, compared to 1% of patients on placebo. Chronic therapy with dofetilide also increased the rate of maintenance of normal sinus rhythm after electro-cardioversion. Dofetilide was approved for use in the United States for atrial fibrillation and flutter in 1999, but its use is restricted and requires physician training in its use as well as initiation of therapy with 3 days of cardiac monitoring and assessment of renal function. Dofetilide is available in capsules of 125, 250 and 500 µg under the brand name Tikosyn. The recommended dose is 500 µg twice daily with dose modification based upon creatinine clearance. Common side effects include headache, dizziness, chest pain and nausea. Uncommon, but potentially severe adverse events include prolongation of the QTc interval (in up to 26%), torsades de pointes (a polymorphic form of ventricular tachycardia), ventricular fibrillation and sudden cardiac death. The frequency of these proarrhythmic side effects is largely dose related.

### Hepatotoxicity

In clinical trials, serum aminotransferase and alkaline phosphatase elevations were no more common during dofetilide than placebo therapy. Some degree of ALT elevation was reported in 15% of dofetilide but a similar proportion of placebo recipients; these elevations were above 3 times the upper limit of normal in 1.5% vs 2.0%. Thus, the background rate of serum ALT elevations in patients with atrial fibrillation eligible for dofetilide treatment appears to be high. Despite this, dofetilide has not been linked to instances of clinically apparent liver injury with symptoms or jaundice. The product label for dofetilide does not mention hepatotoxicity and does not specifically recommend monitoring of liver tests.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which dofetilide might cause liver injury is unknown. Dofetilide has a sulfonamide-like structure, but has not been linked to a high rate of hypersensitivity ("sulfa") reactions. The absence of hepatic side effects may be attributable to the low doses used (1 mg or less daily). Dofetilide is metabolized in the liver predominantly by CYP 3A4 and it is susceptible to multiple drug-drug interactions. Dofetilide should not be used in combination with drugs that inhibit CYP 3A4 activity which can cause increases in drug levels and risks of serious ventricular arrhythmias.

### Outcome and Management

There is little evidence that dofetilide can cause liver injury, but it has a narrow therapeutic-toxic ratio in relation to cardiac arrhythmias, prolongation of the QTc interval and risk for torsades de pointes. There is little information about cross sensitivity to liver injury between other oral antiarrhythmics and dofetilide.

Drug Class: Antiarrhythmic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dofetilide – Generic, Tikosyn®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dofetilide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dofetilide | 115256-11-6 | C19-H27-N3-O5-S2 | Dofetilide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 September 2016

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity of antiarrhythmics published in 1999 before the availability of dofetilide).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents; does not discuss dofetilide).
Sampson KJ, Kass RS. Antiarrhythmic drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 815-48. (Textbook of pharmacology and therapeutics).
Torp-Pedersen C, Møller M, Bloch-Thomsen PE, Køber L, Sandøe E, Egstrup K, Agner E, et al. Dofetilide in patients with congestive heart failure and left ventricular dysfunction. N Engl J Med 1999; 341: 857-65. (Among 1518 patients with congestive heart failure and left ventricular dysfunction treated with dofetilide or placebo for an average of 18 months, treatment was associated with a higher rate of conversion to normal sinus rhythm [12% vs 1%] and a decrease in need for re-hospitalization, but no difference in mortality; adverse event rates were similar in the 2 groups; no mention of ALT elevations or hepatotoxicity). 10486417
Roden DM. Antiarrhythmic drugs: from mechanisms to clinical practice. Heart 2000; 84: 339-46. (Overview of antiarrhythmic drugs which are separated into four classes based upon molecular target: I being sodium channel blockers; II beta blockers; III potassium channel blockers; and, IV calcium channel blockers; some agents having multiple targets). 10956304
Singh S, Zoble RG, Yellen L, Brodsky MA, Feld GK, Berk M, Billing CB Jr. Efficacy and safety of oral dofetilide in converting to and maintaining sinus rhythm in patients with chronic atrial fibrillation or atrial flutter: the symptomatic atrial fibrillation investigative research on dofetilide (SAFIRE-D) study. Circulation 2000; 102: 2385-90. (Among 325 patients with atrial fibrillation-flutter treated with dofetilide [25, 250 or 500 µg] vs placebo twice daily, normal sinus rhythm conversion was more frequent with dofetilide [6-30%] than placebo [1%] and was more frequently maintained [37-58% vs 25%], but torsade de pointes occurred only with dofetilide [n=2; 0.8%] as did sudden cardiac death [n=1]; no mention of ALT elevations or hepatotoxicity). 11067793
Grines CL. Safety and effectiveness of dofetilide for conversion of atrial fibrillation and nesiritide for acute decompensation of heart failure: a report from the cardiovascular and renal advisory panel of the Food and Drug Administration. Circulation. 2000; 101: E200-1. (Review of the safety and efficacy of dofetilide for atrial fibrillation by the FDA; mentions its narrow therapeutic window, need to adjust dose based upon creatinine clearance and multiple potential drug-drug interactions; no mention of ALT elevations or hepatotoxicity). 10831533
Boriani G, Lubinski A, Capucci A, Niederle R, Kornacewicz-Jack Z, Wnuk-Wojnar AM, Borggrefe M, et al.; Ventricular Arrhythmias Dofetilide Investigators. A multicentre, double-blind randomized crossover comparative study on the efficacy and safety of dofetilide vs sotalol in patients with inducible sustained ventricular tachycardia and ischaemic heart disease. Eur Heart J 2001; 22: 2180-91. (Among 135 Italian patients with ischemic heart disease at risk of arrhythmias who were treated with dofetilide [500 µg] or sotalol [160 mg] twice daily, overall rates of adverse events were similar in the two groups; no mention of ALT elevations, hypersensitivity reactions or withdrawals for liver related events). 11913480
Møller M, Torp-Pedersen CT, Køber L. Dofetilide in patients with congestive heart failure and left ventricular dysfunction: safety aspects and effect on atrial fibrillation. The Danish Investigators of Arrhythmia and Mortality on Dofetilide (DIAMOND) Study Group. Congest Heart Fail 2001; 7 (3): 146-50. (In a further analysis of the Danish controlled trial of dofetilide vs placebo in 1518 patients with congestive heart failure [Torp-Pederson 1999], the overall adverse event and mortality rates were similar in the 2 groups, but 25 cases of torsade de pointes ventricular tachycardia occurred with dofetilide [2 deaths] but none with placebo; no mention of ALT elevations or hepatotoxicity). 11828153
McNamara RL, Tamariz LJ, Segal JB, Bass EB. Management of atrial fibrillation: review of the evidence for the role of pharmacologic therapy, electrical cardioversion, and echocardiography. Ann Intern Med 2003; 139: 1018-33. (Systematic review of literature on drugs for atrial fibrillation; mentions that the major safety concern is the potential to induce polymorphic ventricular tachycardia [torsades de pointes], which usually occurs during the first 3 days of treatment and is most common with quinidine and dofetilide [up to 12%]). 14678922
Guanzon AV, Crouch MA. Phase IV trial evaluating the effectiveness and safety of dofetilide. Ann Pharmacother 2004; 38: 1142-7. (Among 107 patients with atrial fibrillation or flutter treated with dofetilide in clinical practice, none developed torsades de pointes although 26% had excessive QTc prolongation, and rates of conversion to and maintenance of normal sinus rhythm were similar or higher than reported in registration trials; no mention of ALT elevations or hepatotoxicity). 15161945
Drugs for cardiac arrhythmias. Treat Guidel Med Lett 2007; 5: 51-8. (Concise review of drugs for arrhythmias; dofetilide is used orally to convert atrial fibrillation and maintain sinus rhythm after cardioversion, but is available only through a restricted distribution program requiring that it be started in the hospital with cardiac monitoring). 17505408
Camm J. Antiarrhythmic drugs for the maintenance of sinus rhythm: risks and benefits. Int J Cardiol 2012; 155: 362-71. (Review of the clinical efficacy and safety of drug therapy for maintenance of sinus rhythm after conversion from atrial fibrillation; mentions the proarrhythmic adverse effects of dofetilide and the frequency of torsades de pointes [0.3-4.7%]). 21708411
Treatment of atrial fibrillation. Med Lett Drugs Ther 2014; 56 (1446): 53-8. (Review of drug therapy of atrial fibrillation; mentions that dofetilide is used for rhythm control, particularly in patients with left ventricular dysfunction, but requires in-hospital dose titration and can cause torsades de pointes). 25046325
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to antiarrhythmics including 5 to amiodarone, 2 to dronedarone, but none to dofetilide). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Dofetilide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dofetilide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dofetilide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dofetilide)